# Zoliflodacin

## OVERVIEW

### Introduction

Zoliflodacin is a recently approved antibiotic used for oral treatment of uncomplicated urogenital gonorrhea. Zoliflodacin therapy is given as a single oral dose of 3 grams and has not been associated with serum aminotransferase elevations or with clinically apparent liver injury.

### Background

Zoliflodacin (zoe” li floe day’ sin) is a unique spiropyrimidinetrione antibiotic that is used to treat uncomplicated urogenital gonorrhea in persons 12 years of age or older. Its mechanism of action is by inhibition of two bacterial type II topoisomerase enzymes (gyrase and topoisomerase, type IV) which blocks bacterial DNA replication. Zoliflodacin is considered bacteriocidal and has activity against many gram positive and negative organisms, including Neisseria gonorrhoeae and its cephalosporin-resistant strains. Zoliflodacin was approved as therapy of uncomplicated urogenital gonorrhea in the United States in 2025 and is available in 3 gram packets of granules under the brand name Nuzolvence. The recommended dose for gonorrhea is 3 grams (1 dose packet) orally once. Common side effects include dizziness, headaches, diarrhea, nausea, abdominal discomfort, flatulence and laboratory abnormalities of neutropenia and lymphopenia. Less common adverse events include hypersensitivity reactions, QTc prolongation, and side effects of acetylcholinesterase inhibition by the drug (such as dysarthria, fainting, muscular spasms, diarrhea, hypersalivation, and sweating). Side effects are usually mild to moderate in severity and brief in duration. Potential severe adverse events are hypersensitivity reactions, including anaphylaxis, Clostridioides difficile diarrhea, bradycardia, syncope, testicular toxicity, and embryo-fetal toxicity (based upon studies in laboratory animals).

### Hepatotoxicity

In a pre-registration, open label trial in 930 patients with uncomplicated gonorrhea, patients received a single dose of zoliflodacin [3 gms given orally] or a single dose of the combination of ceftriaxone [500 mg im] and azithromycin [1 gm orally]. By 4 to 8 days after treatment, 91% of those who received zoliflodacin vs 96% of those on standard therapy were cured. Adverse event rates were similar between the two groups and there were no differences in rates of serum ALT levels within the month after treatment. A small proportion of patients had elevations of ALT above 3 times the upper limit of normal (ULN), but all were attributed to underlying or concurrent disease (pre-existing liver disease, hepatitis C, and COVID-19). No recipient developed liver injury with symptoms or jaundice. Since its approval there have been no published cases of liver injury attributed to zoliflodacin, but clinical experience with the drug has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which zoliflodacin might cause liver injury is not known. It is typically given for 1 day only although in high doses. Longer courses of therapy might have higher rates of adverse events including liver injury. Zoliflodacin is metabolized in the liver primarily by CYP 3A4, and a toxic or immunogenic intermediate of its metabolism might be the cause of liver injury. metabolite might account for liver injury.

### Outcome and Management

Zoliflodacin has not been linked to serum aminotransferase elevations during therapy nor to instances of clinically apparent liver injury. It is given for one day only so that all patients should have stopped therapy by the time that liver injury was detected.

Drug Class: Antiinfective Agents; Antibacterial Agents

Other Drugs in the Subclass: Gepotidacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Zoliflodacin – Nuzolvence®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Zoliflodacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Zoliflodacin | 1620458-09-4 | C22H22FN5O7

ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2026

Abbreviations used: ULN, upper limit of normal; im, intramuscularly.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of zoliflodacin).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65 (Textbook of pharmacology and therapeutics, published before the availability of zoliflodacin).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2026/219491Orig1s000IntegratedR.pdf (FDA website with product label and FDA integrated review of efficacy and safety of zoliflodacin, based upon data submitted by the sponsor in support of its approval as therapy of gonorrhea, mentions that in the large pre-registration randomized controlled trial [Luckey 2026], ALT elevations above 3 times ULN occurred in 1.7% of patients on zoliflodacin vs 1.3% on ceftriaxone and azithromycin, which were above 5 times ULN in 0.7% vs 0.7%, and above 10 times ULN in one zoliflodacin treated subject who had similarly high pre-treatment values; and none of the ALT elevations were accompanied by symptoms or jaundice).
Taylor SN, Marrazzo J, Batteiger BE, Hook EW 3rd, Seña AC, Long J, Wierzbicki MR, et al. Single-dose zoliflodacin (ETX0914) for treatment of urogenital gonorrhea. N Engl J Med. 2018;379:1835-1845. (Among 141 patients with uncomplicated urogenital gonorrhea or recent exposure treated with zoliflodacin [one day of 2 or 3 grams orally] or ceftriaxone [one dose of 150 mg im), microbiologic cure rates were 96% and 96% vs 100%, while adverse event rates were 42% and 66% vs 82%, with no mention of ALT elevations or hepatotoxicity). 30403954
Foerster S, Drusano G, Golparian D, Neely M, Piddock LJV, Alirol E, Unemo M. In vitro antimicrobial combination testing of and evolution of resistance to the first-in-class spiropyrimidinetrione zoliflodacin combined with six therapeutically relevant antimicrobials for Neisseria gonorrhoeae. J Antimicrob Chemother. 2019;74:3521-3529. (Zoliflodacin had potent activity against multiple strains of Neisseria gonorrhea with a low level of resistance with prolonged therapy that was less when it was combined with other agents active against gonorrhea strains). 31730160
Luckey A, Balasegaram M, Barbee LA, Batteiger TA, Broadhurst H, Cohen SE, Delany-Moretlwe S, et al.; Zoliflodacin Phase 3 Study Group. Zoliflodacin versus ceftriaxone plus azithromycin for treatment of uncomplicated urogenital gonorrhea: an international, randomised, controlled, open-label, phase 3, non-inferiority clinical trial. Lancet. 2026;407(10524):147-160. (Among 930 patients with uncomplicated urogenital gonorrhea treated with one day of oral zoliflodacin [3 gm] or one day of the combination of im ceftriaxone [500 mg] and oral azithromycin [1 gm] , cure rates were 91% vs 96% [non-inferior] while adverse event rates were similar [46% vs 46%] and mostly mild to moderate in severity with no serious treatment-related adverse events and no mention of ALT elevations or hepatotoxicity). 41391465
Two new drugs for gonorrhea. Med Lett Drugs Ther. 2026;68(1750):41-43. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of zoliflodacin shortly after its approval in the United States as therapy of uncomplicated urogenital gonorrhea; mentions that serious adverse effects can include atrioventricular block, bradycardia, bronchospasm, seizures, and syncope but does not mention ALT elevations or hepatotoxicity). 41793382

## OTHER REFERENCE LINKS

1. Recent References on Zoliflodacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Zoliflodacin%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Zoliflodacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Zoliflodacin)